# Zolpidem

## OVERVIEW

### Introduction

Zolpidem is a benzodiazepine receptor agonist that is used for the treatment of insomnia. Zolpidem has rarely been implicated in causing serum enzyme elevations and has not been reported to cause clinically apparent liver injury.

### Background

Zolpidem (zol' pi dem) is a non-benzodiazepine, benzodiazepine receptor agonist of the imidazopyridine class that acts by binding to the benzodiazepine (BZ) site on the GABA receptor complex, causing neural inhibition and helping to induce sleep. Zolpidem has selectivity for certain BZ receptor subtypes and does not have the neuromuscular relaxation or anticonvulsant effects of the standard benzodiazepines. Zolpidem has a short half life and rapid onset of action. In multiple placebo controlled trials, zolpidem was shown to decrease the latency to onset of sleep and improve perceived sleep quality with minimal next day residual somnolence or rebound insomnia after withdrawal. Zolpidem was approved for use in the United States in 1992 for the short term treatment of insomnia and is the most commonly prescribed medication for insomnia with more than 10 million prescriptions filled yearly. Zolpidem is available in 5 and 10 mg tablets generically and under the brand name Ambien. The recommended dose is 5 mg taken orally immediately before bedtime. Higher doses should be used with caution as they may result in next-morning impairment in motor activity that may affect driving. Zolpidem is also available in an extended release and in a low dose sublingual form (3.5 mg) for middle-of-the-night awakening. Like the other benzodiazepine receptor agonists, zolpidem is classified as a Schedule IV controlled substance (low potential for abuse and limited physical or psychological dependence). Side effects are uncommon, usually mild and may include headache, nausea, dizziness and drowsiness.

### Hepatotoxicity

In multiple premarketing randomized controlled trials, zolpidem was not associated with an increased rate of serum enzyme elevations in comparison to placebo therapy. A single instance of clinically apparent liver injury has been reported. The onset of injury was 2 days after a single dose of zolpidem and was accompanied by abdominal pain, but no jaundice. The pattern of liver enzyme elevations was hepatocellular and the abnormalities were self-limited, although they seemed to recur on reexposure. Zolpidem is metabolized in the liver by the cytochrome P450 system (predominantly CYP 3A4) and can cause drug-drug interactions, although such interactions are rare. Thus, zolpidem has not been linked to cases of liver injury with jaundice, but rarely may cause transient, mild-to-moderate serum enzyme elevations with or without symptoms.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Sedatives and Hypnotics

Other Drugs in the Subclass, Benzodiazepine Receptor Agonists: Eszopiclone, Zaleplon

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zolpidem – Generic, Ambien®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zolpidem)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zolpidem | 82626-48-0 | C19-H21-N3-O | Zolpidem Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2018

Zimmerman HJ. Anxiolytic agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of hepatotoxicity published in 1999 discusses benzodiazepines and minor tranquilizers before the availability of zolpidem; "In general, the hepatotoxic potential of this widely used group of compounds seems low").
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian all of which have been linked to rare cases of liver injury; no discussion of zolipem).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Garnier R, Guerault E, Muzard D, Azoyan P, Chaumet-Riffaud AE, Efthymiou ML. Acute zolpidem poisoning--analysis of 344 cases. J Toxicol Clin Toxicol 1994; 32: 391-404. (Analysis of 344 cases of intentional zolpidem overdose, 10 to 1,400 mg, resulting in drowsiness in 89 cases, coma in 4 and respiratory failure in 1; ALT elevations occurred in 7 patients but were mild, transient and attributed to other causes, rhabdomyolysis [n=3], chronic hepatitis [n=1], chronic alcohol abuse [n=2] and possibly acute alcohol abuse [n=1]). 8057398
Ganzoni E, Santoni JP, Chevillard V, Sélle M, Mathy B. Zolpidem in insomnia: a 3-year post-marketing surveillance study in Switzerland. J Int Med Res 1995; 23: 61-73. (Prospective, postmarketing surveillance of 1972 Swiss patients ["representative of the general insomniac population"] found 175 [9%] reporting 343 adverse events which led to discontinuation in 5.2%, mostly commonly for daytime sedation, dizziness, nervousness and nightmares; no reports of liver injury). 7774760
Dockhorn RJ, Dockhorn DW. Zolpidem in the treatment of short-term insomnia: a randomized, double-blind, placebo-controlled clinical trial. Clin Neuropharmacol 1996; 19: 333-40. (Controlled trial of zolpidem vs placebo in 136 patients with short term insomnia; most common adverse events were headache [32%], daytime drowsiness [5.8%], diarrhea [4.3%] and dizziness [4.3%]; no changes in laboratory test results). 8828996
Allain H, Monti J. General safety profile of zolpidem: safety in elderly, overdose and rebound effects. Eur Psychiatry 1997; 12 Suppl 1: 21-9. (Review of safety and tolerability of zolpidem in elderly persons focusing upon daytime drowsiness, rebound insomnia, dependence and depression; even with overdose, laboratory abnormalities were not encountered). 19698571
Hajak G, Bandelow B. Safety and tolerance of zolpidem in the treatment of disturbed sleep: a post-marketing surveillance of 16944 cases. Int Clin Psychopharmacol 1998; 13: 157-67. (Postmarketing surveillance study in 16,944 German patients given zolpidem for insomnia; side effects were uncommon; no mention of liver injury). 9727726
Ganzoni E, Gugger M. [Safety profile of zolpidem: two studies of 3805 patients by Swiss practitioners]. Praxis (Bern 1994) 1999; 88: 1120-7. (Analysis of postmarketing surveillance of zolpidem among 3805 Swiss patients found no severe adverse events attributable to drug; no mention of liver injury). 10429550
Gock SB, Wong SH, Nuwayhid N, Venuti SE, Kelley PD, Teggatz JR, Jentzen JM. Acute zolpidem overdose--report of two cases. J Anal Toxicol 1999; 23: 559-62. (Report of two deaths from suspected zolpidem overdose; no mention of liver injury). 10517569
Karsenti D, Blanc P, Bacq Y, Metman EH. Hepatotoxicity associated with zolpidem treatment. BMJ 1999; 318 (7192): 1179. (53 year old woman with recurrent abdominal pain developed jaundice 2 days after taking a single dose of zolpidem [bilirubin 1.2 mg/dL, ALT 596 U/L, Alk P 134 U/L], resolving rapidly, and symptoms recurring after taking it again [ALT 50 U/L]). 10221943
Hajak G, Cluydts R, Declerck A, Estivill SE, Middleton A, Sonka K, Unden M. Continuous versus non-nightly use of zolpidem in chronic insomnia: results of a large-scale, double-blind, randomized, outpatient study. Int Clin Psychopharmacol 2002; 17: 9-17. (Controlled trial of 14 days of nightly vs interrupted [5 of 7 nights/week] zolpidem in 789 patients with insomnia; side effects were mild and self-limited; no mention of hepatotoxicity). 11800507
Roblin X, Boudemaghe T, Paris F, Pellissier L, Le Gall S. [Unexplained increase in aminotransferases and obstructive sleep apnea syndrome]. Gastroenterol Clin Biol 2002; 26: 416-7. French. (45 year old woman found to have minor serum ALT elevations [1.5-3 times ULN] without jaundice or symptoms while taking zolpidem, which improved on stopping, but which were subsequently shown to be due to severe sleep apnea). 12070418
Terzano MG, Rossi M, Palomba V, Smerieri A, Parrino L. New drugs for insomnia: comparative tolerability of zopiclone, zolpidem and zaleplon. Drug Saf 2003; 26: 261-82. (Comparison of adverse events and tolerability of three new drugs for insomnia focusing upon CNS symptoms such as headache, drowsiness and fatigue; mentions rare observations suggestive of hepatotoxicity of zolpidem [Karsenti 1999]). 12608888
Drover DR. Comparative pharmacokinetics and pharmacodynamics of short-acting hypnosedatives: zaleplon, zolpidem and zopiclone. Clin Pharmacokinet 2004; 43: 227-38. (Review of mechanism of action, pharmacology, efficacy and adverse effects of 3 non-benzodiazepine hypnotic agents: zaleplon, zolpidem and zopiclone). 15005637
Roth T, Soubrane C, Titeux L, Walsh JK; Zoladult Study Group. Efficacy and safety of zolpidem-MR: a double-blind, placebo-controlled study in adults with primary insomnia. Sleep Med 2006; 7: 397-406. (Controlled trial of a modified release zolpidem vs placebo in 212 patients with chronic insomnia; side effects were mild and similar in frequency with placebo; no mention of ALT elevations or hepatotoxicity). 16815744
Roth T, Hull SG, Lankford DA, Rosenberg R, Scharf MB; Intermezzo Study Group. Low-dose sublingual zolpidem tartrate is associated with dose-related improvement in sleep onset and duration in insomnia characterized by middle-of-the-night(MOTN) awakenings. Sleep 2008; 31: 1277-84. (Controlled trial of sublingual low dose zolpidem vs placebo in 82 patients; side effects were few, mild and transient). 18788653
Krystal AD, Erman M, Zammit GK, Soubrane C, Roth T; ZOLONG Study Group. Long-term efficacy and safety of zolpidem extended-release 12.5 mg, administered 3 to 7 nights per week for 24 weeks, in patients with chronic primary insomnia: a 6-month, randomized, double-blind, placebo-controlled, parallel-group, multicenter study. Sleep 2008; 31: 79-90. (Controlled trial of extended release zolpidem vs placebo for 3 to 7 nights per week for 24 weeks in 1018 patients with chronic insomnia; averse events included headache, anxiety and somnolence; no mention of liver related toxicities). 18220081
Walsh JK, Soubrane C, Roth T. Efficacy and safety of zolpidem extended release in elderly primary insomnia patients. Am J Geriatr Psychiatry 2008; 16: 44-57. (Controlled trial of zolpidem vs placebo in 205 elderly patients with chronic insomnia found no differences in rates of adverse events between zolpidem and placebo; no mention of laboratory test results). 18165461
Czopowicz M, Szalus-Jordanow O, Frymus T. Zolpidem poisoning in a cat. Aust Vet J 2010; 88: 326-7. (16 year old neutered cat was given 5 mg of zolpidem in error and developed stupor and disorientation which responded to hydration and support; there were no changes in preexisting mild elevations of serum enzymes). 20633172
Ben-Hamou M, Marshall NS, Grunstein RR, Saini B, Fois RA. Spontaneous adverse event reports associated with zolpidem in Australia 2001-2008. J Sleep Res 2011; 20(4): 559-68. (Analysis of adverse event reporting in Australia suggested higher odds for "parasomnia", amnesia and hallucinations with use of zolpidem than other hypnotics). 21481053
Randall S, Roehrs TA, Roth T. Efficacy of eight months of nightly zolpidem: a prospective placebo-controlled study. Sleep 2012; 35: 1551-7. (Controlled trial of zolpidem vs placebo nightly for 8 months in 88 patients with insomnia; side effects were not formally reported). 23115404
Drugs for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guidelines for therapy of insomnia mentions that benzodiazepine receptor agonists such as zaleplon, benzodiazepines, ramelteon and low doses of doxepin are effective and generally safe; the discussion of adverse events makes no mention of ALT elevations or hepatotoxicity of any of the recommended agents). 22777275
Roth T, Krystal A, Steinberg FJ, Singh NN, Moline M. Novel sublingual low-dose zolpidem tablet reduces latency to sleep onset following spontaneous middle-of-the-night awakening in insomnia in a randomized, double-blind, placebo-controlled, outpatient study. Sleep 2013; 36: 189-96. (Among 295 adults with middle-of-the-night awakening treated with either sublingual zolpidem or placebo for 2 weeks, adverse events were similar in both groups; no mention of ALT elevations or liver toxicity). 23372266
MacFarlane J, Morin CM, Montplaisir J. Hypnotics in insomnia: the experience of zolpidem. Clin Ther 2014; 36: 1676-1701. (Review of efficacy and safety of zolpidem for insomnia based on 13 postmarketing studies in more than 61,000 patients states: "Zolpidem does not have any adverse effects on liver, cardiovascular, or renal function"). 25455931
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a sleeping aid, despite the fact that zopiclone and zolpidem are among the 25 most commonly prescribed drugs in Iceland). 23419359
https://www.fda.gov/downloads/Drugs/DrugSafety/UCM335007.pdf (FDA letter warning of the next-morning impairment including driving ability after use of insomnia drugs and recommendation of use of lower doses, particularly for women).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to zolpidem or other sedatives or sleeping aids). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25444550) (Among 76 cases of suspected drug induced liver injury and 377 controls enrolled in a German, prospective hospital based registry, 9 cases but also 15 controls had been exposed to zolpidem, a difference that was not statistically significant).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to agents active in the central nervous system, but none were due to zolpidemi or other sedatives or sleeping aids). 25754159
Drugs for insomnia. Med Lett Drugs Ther 2015; 57 (1472): 95-8. (Concise review of the mechanism of action, efficacy, safety and costs of drugs for insomnia including benzodiazepine receptor agonists including zolpidem as well as benzodiazepines, melatonin receptor agonists, orexin receptor antagonists and other agents including nonprescription and herbal products). 26147892

## OTHER REFERENCE LINKS

1. Recent References on Zolpidem: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Zolpidem/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Zolpidem: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zolpidem)